# Sibutramine

## OVERVIEW

### Introduction

Sibutramine is a serotonin and norepinephrine reuptake inhibitor which has been used for short- and long-term therapy of obesity, but which was withdrawn from use in the United States in 2010 because of increased risk of cardiovascular events. In large clinical trials, sibutramine therapy was not associated with serum enzyme elevations, and it has only rarely been implicated in cases of clinically apparent, acute liver injury.

### Background

Sibutramine (si bue' tra meen) is a beta-phenylethylamine that inhibits the synaptic reuptake of both serotonin and norepinephrine. Developed initially as an antidepressant, it had little effect on depression, but its use was associated with weight loss that appeared to be due to decreased appetite and reduced caloric intake. Sibutramine was approved for use as therapy of obesity in the United States in 1997 and was widely prescribed until it was withdrawn in 2010 because of studies demonstrating an increased risk of myocardial infarction and stroke with its use. Sibutramine was previously available as capsules of 5, 10 and 15 mg under the trade name Meridia. The recommended dose was 10 mg once daily, with adjustment up to 15 mg daily or down to 5 mg daily based upon clinical effect and tolerance. Common side effects included dry mouth, headache, insomnia, constipation, nausea and increased blood pressure and heart rate. While no longer available commercially, sibutramine has been found as a contaminant in in some weight loss products available over-the-counter or via the internet.

### Hepatotoxicity

Sibutramine has not been linked to an increased rate of serum enzyme elevations during therapy, but the results of serum ALT monitoring have been reported only rarely. Despite its long term availability, only a single case report of acute liver injury attributed to sibutramine has been published. The time to onset was 2 weeks and the pattern of liver enzyme elevation was cholestatic. The liver injury was anicteric and self-limited in course (Case 1). Immunoallergic and autoimmune features were absent. There have been no reports of acute liver failure or chronic liver injury attributed to sibutramine.

### Mechanism of Injury

The mechanism by which sibutramine might cause liver injury is not known. Sibutramine undergoes extensive hepatic metabolism, primarily by the cytochrome P450 system (CYP 3A4) to its active metabolite which may be further metabolized and conjugated in the liver. Thus, a possible mode of liver injury is production of a toxic intermediate.

Drug Class: Weight Loss Agents

## CASE REPORT

### Case 1. Anicteric acute liver injury attributed to sibutramine use.(1)

A 47 year old obese woman with type 2 diabetes developed fatigue, weakness and pruritus followed by dark urine and jaundice arising 2 weeks after starting sibutramine (10 mg daily). She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. Her only other medication was insulin. She drank herbal tea. Sibutramine was taken for a total of 20 days and stopped once liver injury was identified. Laboratory testing showed normal serum bilirubin levels, but moderate elevations in ALT (222 U/L), AST (98 U/L) and alkaline phosphatase (763 U/L) (Table). Serological tests for viral hepatitis were negative as were routine autoantibodies. Abdominal ultrasound, computerized tomography and magnetic resonance imaging showed a small gallbladder polyp, but no evidence of liver enlargement or biliary obstruction. A liver biopsy showed a mixed inflammatory infiltrate without fibrosis or cholestasis. Upon stopping the medication, she began to improve clinically and laboratory tests fell rapidly and were normal when tested 8 months later.

#### Key Points

Medication: | Sibutramine (10 mg daily)
Pattern: | Cholestatic (R=0.8)
Severity: | 1+ (enzyme elevations without jaundice)
Latency: | 2 weeks to symptoms, 3 weeks to jaundice
Recovery: | 2-3 months
Other medications: | Insulin, herbal tea

#### Laboratory Values

Time After Starting | Weeks After Stopping | ALT (U/L) | Alk P (U/L) | GGT (U/L) | Other
3 weeks | 0 | 222 | 763 | 925 | Sibutramine stopped
9 weeks | 6 weeks | 41 | 179 | 228 | Asymptomatic
5 months | 4 months | 29 | 154 | 60
7 months | 6 months | 70 | 139 | 92
9 months | 8 months | 33 | 75 | 30
Normal Values | | <42 | <115 | <50

#### Comment

The timing of onset of liver test abnormalities, the cholestatic pattern of enzyme elevations and the liver histology were all compatible with drug induced liver injury, and the only apparent candidate was sibutramine. Normalization of the alkaline phosphatase and GGT were delayed, but this is common after cholestatic liver injury. The lack of bilirubin elevation indicates that the injury, while symptomatic, was mild.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sibutramine – Meridia®

DRUG CLASS

Weight Loss Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=sibutramine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Sibutramine | 106650-56-0 | C17-H26-Cl-N

## CITED REFERENCE

1 Chounta A, Tsiodras S, Zouridakis S, Doumas M, Giamarellou H. (2005). Sibutramine use associated with reversible hepatotoxicity. Ann Intern Med.

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-91. (Expert review of hepatotoxicity published in 1999; sibutramine is not mentioned).
Sibley DR, Hazelwood LA, Amara SG. 5-Hydroxytryptamine (serotonin) and dopamine. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. p. 225-42. (Textbook of pharmacology and therapeutics).
Luque CA, Rey JA. (1999). Sibutramine: a serotonin-norepinephrine reuptake-inhibitor for the treatment of obesity. Ann Pharmacother. (Review of chemistry, pharmacology, metabolism, clinical efficacy and safety of sibutramine; no mention of hepatitis or ALT elevations in discussion of side effects).
Bray GA. (2000). A concise review on the therapeutics of obesity. Nutrition. (Overview of the mechanism of action of antiobesity medications and their clinical efficacy and side effects; no mention of ALT elevations or liver related adverse events).
Haddock CK, Poston WS, Dill PL, Foreyt JP, Ericsson M. (2002). Pharmacotherapy for obesity: a quantitative analysis of four decades of published randomized clinical trials. Int J Obes Relat Metab Disord. (Metaanalysis of published studies of anti-obesity medications; sibutramine has been studied in 5 controlled trials published between 1991-98; no discussion of side effects).
Sabuncu T, Nazligul Y, Karaoglanoglu M, Ucar E, Kilic FB. (2003). The effects of sibutramine and orlistat on the ultrasonographic findings, insulin resistance and liver enzyme levels in obese patients with non-alcoholic steatohepatitis. Rom J Gastroenterol. (Trial of 6 month course of sibutramine [n=13] vs orlistat [n=12] in 25 obese patients with nonalcoholic steatohepatitis; both agents were associated with weight loss and improvements in hepatic fat and ALT levels [79 to 32 U/L], but slight increase in Alk P [~175 to ~196 U/L]; no patient stopped therapy because of side effects).
Colman E. (2005). Anorectics on trial: a half century of federal regulation of prescription appetite suppressants. Ann Intern Med. (History of the approval of medications for obesity from initial agents approved in 1947 to sibutramine in 1997; sibutramine was approved in 1997, but its long term usefulness and safety remain controversial).
Li Z, Maglione M, Tu W, Mojica W, Arterburn D, Shugarman LR, Hilton L, et al. (2005). Meta-analysis: pharmacologic treatment of obesity. Ann Intern Med. (Systematic review of efficacy and safety of medications for obesity; sibutramine effects were evaluated in 29 published studies which showed an overall significant effect on weight loss when combined with lifestyle modification; no serious adverse events and no mention of hepatotoxicity).
Chounta A, Tsiodras S, Zouridakis S, Doumas M, Giamarellou H. (2005). Sibutramine use associated with reversible hepatotoxicity. Ann Intern Med. (47 year old woman developed fatigue and pruritus 2 weeks after starting a 20 day course of sibutramine [bilirubin normal, ALT 222 U/L, Alk P 763 U/L], resolving 6-8 months after stopping: Case 1).
Bray GA. (2005). Drug Insight: appetite suppressants. Nat Clin Pract Gastroenterol Hepatol. (Review of the mechanism of action and clinical efficacy of drugs that suppress appetite including sympathomimetic agents [amphetamine, phentermine, sibutramine], serotonin reuptake inhibitors [bupropion, fenfluramine, fluoxetine], GABAergic agents [topiramate, zonisamide], cannabinoid antagonists [rimonabant] and various peptides [leptin, neuropeptide Y, melanocortin-4]; no discussion of hepatotoxicity).
Ioannides-Demos LL, Proietto J, Tonkin AM, McNeil JJ. (2006). Safety of drug therapies used for weight loss and treatment of obesity. Drug Saf. (Review of safety of drug therapy of obesity; the only mention of liver adverse events was “a case of reversible hepatotoxicity associated with sibutramine”).
James WP, Caterson ID, Coutinho W, Finer N, Van Gaal LF, Maggioni AP, Torp-Pedersen C, et al. (2010). SCOUT Investigators. Effect of sibutramine on cardiovascular outcomes in overweight and obese subjects. N Engl J Med. (Controlled trial of sibutramine vs placebo for an average of 3.4 years in 10,744 overweight or obese subjects with preexisting cardiovascular conditions, found increases in pulse rate, blood pressure, and nonfatal myocardial infarction and stokes; no mention of ALT levels or hepatotoxicity).
(2010). Sibutramine (Meridia) withdrawn. Med Lett Drugs Ther. (Announcement that sibutramine was withdrawn from the market because of concerns over cardiovascular safety in the US, Canada, Europe and Australia, but remains available in other countries).
van Hunsel F, van Grootheest K. (2011). Ned Tijdschr Geneeskd. (Two reports of adverse events due to "Green Coffee 800", an unregistered weight loss agent that was found to be contaminated with sibutramine; one patient had serum ALT elevations).
Ozdemir B, Sahin I, Kapucu H, Celbis O, Karakoc Y, Erdogan S, Onal Y. (2013). How safe is the use of herbal weight-loss products sold over the Internet?. Hum Exp Toxicol. (Testing of 9 weight loss products sold over the Internet found that all 9 had undeclared ingredients, 3 having sibutramine).
Kang JG, Park CY. (2012). Anti-obesity drugs: a review about their effects and safety. Diabetes Metab J. (Review of the safety and efficacy of current and potentially future medications for obesity; mentions that the five year cardiovascular outcomes study of sibutramine [James 2010] demonstrated a significant increase in pulse, blood pressure, and risk of nonfatal myocardial infarction and stroke which led to its withdrawal in October 2010).
Reeuwijk NM, Venhuis BJ, de Kaste D, Hoogenboom RL, Rietjens IM, Martena MJ. (2014). Active pharmaceutical ingredients detected in herbal food supplements for weight loss sampled on the Dutch market. Food Addit Contam Part A Chem Anal Control Expo Risk Assess. (Sampling of 50 herbal weight loss product by the Netherlands Food and Consumer Product Safety Authority found pharmaceutically active adulterants not listed on the product label in in 24, most commonly sibutramine [n=17] but also rimonabant, sildenafil and phenolphthalein often in pharmacologically significant amounts).
Ching CK, Chen SPL, Lee HHC, Lam YH, Ng SW, Chen ML, Tang MHY, et al. (2018). Adulteration of proprietary Chinese medicines and health products with undeclared drugs: experience of a tertiary toxicology laboratory in Hong Kong. Br J Clin Pharmacol. (Over a 10 year period 487 adulterated proprietary Chinese medical products were identified by a toxicology laboratory in Hong Kong, the contaminants being mostly NSAIDs, anorectics, corticosteroids and diuretics, the single most common contaminant being sibutramine [present in 155 products: 32%]).
Dedov II, Melnichenko GA, Troshina EA, Mazurina NV, Galieva MO. (2018). Body weight reduction associated with the sibutramine treatment: overall results of the PRIMAVERA primary health care trial. Obes Facts. (Among 98,774 patients enrolled in a sibutramine treatment program in Russia, therapy with sibutramine resulted in weight loss in most subjects and there were no serious adverse events; no mention of ALT levels or hepatotoxicity).
Biesterbos JWH, Sijm DTHM, van Dam R, Mol HGJ. (2019). A health risk for consumers: the presence of adulterated food supplements in the Netherlands. Food Addit Contam Part A Chem Anal Control Expo Risk Assess. (Analysis of 416 commercial dietary supplements by the Netherlands Food and Consumer Product Safety Authority between 2013 and 2018 identified 264 [64%] as having an adulterant, the most common being caffeine and synephrine, sildenafil, icariin, higenamine and sibutramine [n=22: 5.2%]).

## OTHER REFERENCE LINKS

1 Recent References on Sibutramine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Sibutramine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Sibutramine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sibutramine)